# Afatinib

## OVERVIEW

### Introduction

Afatinib is a tyrosine kinase receptor inhibitor that is used in the therapy of selected forms of metastatic non-small cell lung cancer. Afatinib is associated with a high rate of transient serum aminotransferase elevations during therapy and with rare instances of clinically apparent liver injury, some of which are due to reactivation of hepatitis B.

### Background

Afatinib (a fa' ti nib) is a small molecule tyrosine kinase receptor of the epidermal growth factor receptor (EGFR or ErbB1), human epidermal growth factor receptor 2 (HER2 or ErbB2) and HER4 (ErbB4). These tyrosine kinase receptors are often mutated and over expressed in tumor tissue and cause unregulated cell growth and proliferation. Inhibition of the unregulated receptor can lead to reversal of progression of the cancer, although clinical responses are sometimes limited by the development of tumor resistance caused by further mutations in the receptor gene. In several large controlled trials, afatinib was shown to improve progression-free survival in patients with non-small cell lung cancer (NSCLC) with mutated EGFR. Afatinib received approval for use in the United States in 2013. Current indications are as first line therapy for metastatic NSCLC with sensitive EGFR mutations and as therapy of refractory metastatic squamous cell lung cancer. Afatinib is available in tablets of 20, 30 and 40 mg under the brand name Gilotrif. The recommended dose is 40 mg once daily which is continued until disease progression or intolerable toxicity. Side effects are common and include diarrhea, rash, stomatitis, paronychia, dry skin, decreased appetite, nausea, vomiting and pruritus. Uncommon, but potentially severe side effects include severe diarrhea leading to dehydration and renal failure, bullous and exfoliative skin rashes, Stevens Johnson syndrome and toxic epidermal necrolysis, interstitial lung disease, gastrointestinal perforation, keratitis, hepatic toxicity and embryo-fetal toxicity.

### Hepatotoxicity

Elevations in serum aminotransferase levels are common during afatinib therapy and occurred in 20% to 50% of patients in the pre-registration pivot trials, but rose above 5 times the upper limit of the normal range in only 2% to 3%. Hepatic failure was said to have occurred in 0.2% of patients and to have resulted in several fatalities. Hepatotoxicity appears to be a class effect among protein kinase inhibitors of EGFR, although significant liver injury appears to be more frequent and more severe with gefitinib than with afatinib and erlotinib. Despite over a decade of use, specific details of the liver injury associated with afatinib such as latency, serum enzyme pattern, clinical features and course, have not been published. Other EGFR inhibitors, such as erlotinib and gefitinib typically cause liver injury arising within days or weeks of starting therapy and present abruptly with hepatocellular enzyme elevations and a moderate-to-severe course. Immunoallergic and autoimmune features are not common. The rate of clinically significant liver injury and hepatic failure is increased in patients with preexisting cirrhosis or hepatic impairment due to liver tumor burden.

Afatinib, like other tyrosine kinase inhibitors of the EGFR, has been linked to reactivation of hepatitis B in up to 10% of patients who are HBsAg positive and are treated for at least a year. Levels of HBV DNA usually begin to rise within a few months of therapy and at least half have an accompanying hepatitis flare. For this reason, patients should be screened for hepatitis B markers before starting therapy and those with HBsAg in serum should be given prophylaxis with a potent oral antiviral agent with activity against HBV or be monitored for changes in ALT and HBV DNA. Patients with de novo appearance or with rising levels of HBV DNA should be started on antiviral therapy. Deaths due to HBV reactivation during afatinib therapy have not been reported, but experience is limited. Cases of HBV reactivation in patients without HBsAg but with anti-HBc in serum have not been reported, but such patients warrant monitoring.

Likelihood score: C (probable rare cause of clinically apparent liver injury including reactivation of hepatitis B).

### Mechanism of Injury

The transient serum aminotransferase elevations that are common during therapy with afatinib are probably due to direct hepatotoxicity, perhaps caused by inhibition of critical tyrosine kinase receptor pathways in hepatocytes. The clinically apparent cases of afatinib liver injury are likely idiosyncratic and immune mediated. The lower rate of liver injury with afatinib vs gefitinib and erlotinib probably relates to its lack of extensive hepatic metabolism. The EGFR inhibitors can cause reactivation of hepatitis B in patients with pre-existing chronic HBV infection (HBsAg in serum), the mechanism of which is unknown but is possibly due to immunosuppression.

### Outcome and Management

Liver injury due to afatinib varies in severity from minor, transient serum enzyme elevations to acute symptomatic hepatitis and, rarely, hepatic failure. Periodic monitoring of liver tests during afatinib therapy is recommended. Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to temporary discontinuation, which should be made permanent if laboratory values do not improve significantly or resolve within a few weeks, or if symptoms or jaundice arise. Corticosteroids have been used in some instances of acute liver injury due to EGFR inhibitors, but their value is unproven. There does not appear to be cross reactivity in risk for hepatic injury among the tyrosine kinase receptor inhibitors, and patients who develop liver test abnormalities on gefitinib or erlotinib have generally tolerated afatinib.

Because a rise in serum enzymes may represent reactivation of hepatitis B rather than injury from the drug, patients should be screened for HBsAg before starting therapy, and those who are positive followed with hepatitis B virus DNA levels or given antiviral prophylaxis.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other Drugs in the Subclass, EGFR Inhibitors: Dacomitinib, Erlotinib, Gefitinib, Osimertinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Afatinib – Gilotrif®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Afatinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Afatinib | 850140-72-6 | C24-H25-Cl-F-N5-O3 | SID: 135267496

## ANNOTATED BIBLIOGRAPHY

References updated: 30 July 2026

Abbreviations used: EGFR, epidermal growth factor receptor; HBsAg, hepatitis B surface antigen; HBV, hepatitis B virus; HER-2, human epidermal growth factor receptor-2; NSCLC, non-small cell lung cancer; TKI, tyrosine kinase inhibitor.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors).
DeLeve LD. Kinase inhibitors. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556-7. (Review of hepatotoxicity of cancer chemotherapeutic agents; discusses liver injury attributed to tyrosine kinase inhibitors gefitinib, erlotinib and crizotinib but not afatinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website with product labels, approval letters and the full FDA scientific review of new agents; the medical review of afatinib reported hepatic impairment in 10% of 3865 patients treated in clinical trials with 7 fatal hepatic events [0.2%], only 3 of which were considered drug related; in the pivotal trial, ALT elevations above 5 times ULN arose in 8 afatinib and 2 chemotherapy treated patients, all transient and none leading to discontinuation).
Schacher-Kaufmann S, Pless M. Acute fatal liver toxicity under erlotinib. Case Rep Oncol 2010; 3: 182-8. (53 year old with non-small cell lung cancer developed anorexia 9 days and abdominal pain and fever 17 days after starting erlotinib [bilirubin 4.7 mg/dL, ALT 884 U/L, Alk P 814 U/L], with progressive liver failure and thrombotic microangiopathy, dying 2 weeks after stopping erlotinib). 20740194
Gunturu KS, Abu-Khalaf M, Saif MW. Hepatic failure and hepatorenal syndrome secondary to erlotinib: a possible etiology of complications in a patient with pancreatic cancer. JOP 2010; 11: 484-5. (A 39 year old man with advanced pancreatic cancer developed weakness and rash after 3 days of erlotinib therapy [bilirubin 4.0 rising to 17.2 mg/dL, ALT 489 U/L], rapidly progressing to liver failure associated with diffuse liver metastases and malignant ascites). 20818124
Lai YC, Lin PC, Lai JI, Hsu SY, Kuo LC, Chang SC, Wang WS. Successful treatment of erlotinib-induced acute hepatitis and acute interstitial pneumonitis with high-dose corticosteroid: a case report and literature review. Int J Clin Pharmacol Ther 2011; 49: 461-6. (A 74 year old man developed interstitial pneumonitis and mild serum enzyme elevations one month after starting erlotinib [ALT 116 U/L], both of which improved within days on high dose corticosteroids). 21726497
Schuler M, Awada A, Harter P, Canon JL, Possinger K, Schmidt M, De Grève J, et al. A phase II trial to assess efficacy and safety of afatinib in extensively pretreated patients with HER2-negative metastatic breast cancer. Breast Cancer Res Treat 2012; 134: 1149-59. (Among 50 women with HER2-negative metastatic breast cancer treated with afatinib, there were no objective responses and 96% of patients had adverse events which were serious in 40%; no mention of liver related events). 22763464
Miller VA, Hirsh V, Cadranel J, Chen YM, Park K, Kim SW, Zhou C, et al. Afatinib versus placebo for patients with advanced, metastatic non-small-cell lung cancer after failure of erlotinib, gefitinib, or both, and one or two lines of chemotherapy(LUX-Lung 1): a phase 2b/3 randomised trial. Lancet Oncol 2012; 13: 528-38. (Among 585 patients with previously treated metastatic NSCLC treated with afatinib or placebo, progression-free survival was 3.3 months with afatinib vs 1.1 months with placebo, while adverse events included diarrhea in 87% and acneiform rash in 78%; no mention of liver related adverse events). 22452896
Yoshida T, Yamada K, Azuma K, Kawahara A, Abe H, Hattori S, Yamashita F, et al. Comparison of adverse events and efficacy between gefitinib and erlotinib in patients with non-small-cell lung cancer: a retrospective analysis. Med Oncol 2013; 30: 349. (Comparison of side effects in 107 patients with NSCLC treated with gefitinib and 35 with erlotinib found "liver dysfunction" more frequent with gefitinib [13% vs 6%], whereas overall adverse events leading to drug discontinuation were less common [13% vs 26%]). 23263831
Sequist LV, Yang JC, Yamamoto N, O'Byrne K, Hirsh V, Mok T, Geater SL, et al. Phase III study of afatinib or cisplatin plus pemetrexed in patients with metastatic lung adenocarcinoma with EGFR mutations. J Clin Oncol 2013; 31: 3327-34. (Among 345 patients with metastatic NSCLC with EGFR mutations treated with afatinib or cyclic chemotherapy with cisplatin and pemetrexed, progression-free survival was longer with afatinib [11.1 vs 6.9 months]; side effects were common, but no mention of ALT elevations or hepatotoxicity). 23816960
Wu YL, Zhou C, Hu CP, Feng J, Lu S, Huang Y, Li W, et al. Afatinib versus cisplatin plus gemcitabine for first-line treatment of Asian patients with advanced non-small-cell lung cancer harbouring EGFR mutations (LUX-Lung 6): an open-label, randomised phase 3 trial. Lancet Oncol 2014; 15: 213-22. (Among 364 patients with EGFR-mutant NSCLC treated with afatinib [40 mg daily] or gemcitabine and cisplatin [6 3-week cycles], median progression free survival was longer with afatinib [11 vs 5.6 months], while overall and serious adverse event rates were similar; ALT elevations arising in 20% vs 16% and levels above 5 times ULN in 1.7% vs 2.7%, but no mention of clinically apparent liver injury). 24439929
Cortés J, Dieras V, Ro J, Barriere J, Bachelot T, Hurvitz S, Le Rhun E, et al. Afatinib alone or afatinib plus vinorelbine versus investigator's choice of treatment for HER2-positive breast cancer with progressive brain metastases after trastuzumab, lapatinib, or both (LUX-Breast 3): a randomised, open-label, multicentre, phase 2 trial. Lancet Oncol 2015; 16: 1700-10. (Among 121 women with advanced HER-2 positive breast cancer treated with afatinib alone, afatinib and vinorelbine, or standard of care chemotherapy, overall and progression-free survival were similar in the three groups, but afatinib was associated with more frequent adverse events and discontinuations [43% and 43% vs 7%]; no mention of ALT elevations or clinically apparent liver injury). 26596672
Soria JC, Felip E, Cobo M, Lu S, Syrigos K, Lee KH, Göker E, et al.; LUX-Lung 8 Investigators. Afatinib versus erlotinib as second-line treatment of patients with advanced squamous cell carcinoma of the lung (LUX-Lung 8): an open-label randomised controlled phase 3 trial. Lancet Oncol 2015; 16: 897-907. (Among 795 patients with advanced, squamous cell cancer of the lung treated with afatinib or erlotinib, progression-free survival was longer with afatinib [2.4 vs 1.9 months], while overall [99% vs 97%] and serious [44% vs 44%] adverse event rates were similar; ALT elevations above 5 times ULN occurred in 1.1% vs 0.3%, but no mention of clinically apparent liver injury). 26156651
Takeda M, Okamoto I, Nakagawa K. Pooled safety analysis of EGFR-TKI treatment for EGFR mutation-positive non-small cell lung cancer. Lung Cancer 2015; 88: 74-9. (A pooled analysis of 21 trials of tyrosine kinase inhibitors of EGFR found higher reported rates of "grade 3" hepatotoxicity with gefitinib [18%] than with erlotinib [5.4%] and afatinib [1.7%], and hepatotoxicity was listed as the cause of drug discontinuation in 25% of cases). 25704957
Afatinib (Gilotrif) for advanced non-small cell lung cancer. Med Lett Drugs Ther 2015; 57 (1469): e82-3. (Concise review of the mechanism of action, clinical efficacy, safety and costs of afatinib shortly after its approval in the US as therapy of metastatic NSCLC; mentions that there have been fatalities from hepatic toxicity). 26039556
Yang JC, Wu YL, Schuler M, Sebastian M, Popat S, Yamamoto N, Zhou C, et al. Afatinib versus cisplatin-based chemotherapy for EGFR mutation-positive lung adenocarcinoma (LUX-Lung 3 and LUX-Lung 6): analysis of overall survival data from two randomised, phase 3 trials. Lancet Oncol 2015; 16: 141-51. (Pooled analysis of two trials of afatinib vs standard chemotherapies for NSCLC found similar overall survival rates; no mention of ALT elevations or liver toxicity from afatinib). 25589191
Park K, Tan EH, O'Byrne K, Zhang L, Boyer M, Mok T, Hirsh V, et al. Afatinib versus gefitinib as first-line treatment of patients with EGFR mutation-positive non-small-cell lung cancer (LUX-Lung 7): a phase 2B, open-label, randomised controlled trial. Lancet Oncol 2016; 17: 577-89. (Among 319 patients with EGFR mutant positive NSCLC treated with afatinib [40 mg] or gefitinib [250 mg] daily, progression- free survival was similar in both groups [11.0 vs 10.9 months] as were overall rates of adverse events, although ALT or AST elevations were less frequent with afatinib [all elevations 10% vs 24%, elevations above 5 times ULN 0% vs 1%] and one patient on gefitinib developed fatal acute liver failure). 27083334
Toba H, Sakiyama S, Takizawa H, Tangoku A. Safe and successful treatment with afatinib in three postoperative non-small cell lung cancer patients with recurrences following gefitinib/erlotinib-induced hepatotoxicity. J Med Invest 2016; 63: 149-51. (Three patients with metastatic NSCLC developed ALT elevations during gefitinib therapy [316, 414 and 687 U/L], one of whom also had ALT elevations with erlotinib [442 U/L] later tolerated afatinib treatment without recurrence of liver test abnormalities). 27040072
Ding PN, Lord SJ, Gebski V, Links M, Bray V, Gralla RJ, Yang JC, et al. Risk of treatment-related toxicities from EGFR tyrosine kinase inhibitors: a meta-analysis of clinical trials of gefitinib, erlotinib, and afatinib in advanced EGFR-mutated non-small cell lung cancer. J Thorac Oncol 2017; 12 (4): 633-43. (In a systematic review of 16 trials of EGFR tyrosine kinase inhibitors, liver enzyme elevations were highest for gefitinib [62%] vs afatinib [20%] and erlotinib [18%]). 28007626
Tanaka H, Inomata M, Hayashi R, Shimokawa K, Tokui K, Okazawa S, Kambara K, et al. [A case of lung adenocarcinoma presenting with leptomeningeal carcinomatosis successfully treated with afatinib after erlotinib-induced hepatotoxicity]. Gan To Kagaku Ryoho. 2017;44:595-597. Japanese. 28790264 (Abstract only; 65 year old man with brain metastases from NSCLC developed hepatotoxicity during erlotinib therapy, but then had a clinical response to afatinib without recurrence of liver test abnormalities).
Imai H, Kaira K, Suzuki K, Anzai M, Tsuda T, Ishizuka T, Kuwako T, et al. A phase II study of afatinib treatment for elderly patients with previously untreated advanced non-small-cell lung cancer harboring EGFR mutations. Lung Cancer. 2018;126:41-47. (Among 40 elderly patients with NSCLC treated with afatinib, the overall objective response rate was 72%, but 95% required a dose modification and 8 [20%] stopped therapy because of adverse events, but only one for a liver-related event, while some degree of ALT elevations arose in 35%, they were above 5 times ULN in in only 10%; no mention of clinically apparent liver injury). 30527191
Yao ZH, Liao WY, Ho CC, Chen KY, Shih JY, Chen JS, Lin ZZ, et al. Incidence of hepatitis B reactivation during epidermal growth factor receptor tyrosine kinase inhibitor treatment in non-small-cell lung cancer patients. Eur J Cancer 2019; 117: 107-15. (Among 171 HBsAg-positive adults with NSCLC who were treated with a tyrosine kinase inhibitor of EGFR between 2011 and 2017 at a single Taiwanese referral center, 16 [14%] developed evidence of HBV reactivation after a median of 6 [range 0.6 to 40] months including 6 [11%] on erlotinib, 5 [11%] gefitinib, and 5 of 47 [11%] afatinib). 31279301
Wu Z, Chen S, Du X, Wu Y, Xie X. Hepatotoxicity with epidermal growth factor receptor tyrosine kinase inhibitors in non-small-cell lung cancer patients: a network meta-analysis. J Clin Pharm Ther 2021; 46: 310-8. (Systematic review identified 12 publications that included 6280 patients with NSCLC who received a tyrosine kinase inhibitor of EGFR found evidence of increased risk of ALT elevations in comparison to placebo for gefitinib and dacomitinib while the risk increase was “uncertain” for afatinib and erlotinib ). 33031574
Chang JW, Chang CF, Huang CY, Yang CT, Kuo CHS, Fang YF, et al. The survival after discontinuation of EGFR-TKIs due to intolerable adverse events in patients with EGFR-mutated non-small cell lung cancer. Thorac Cancer 2023; 14: 348-56. (Among 635 patients with NSCLC treated with afatinib at a single Taiwanese referral center, 51 required drug discontinuation because of adverse events, but for either diarrhea or skin rash in most cases, only one for liver test abnormalities; 42 patients subsequently tolerated treatment with a different kinase inhibitor). 36525509
Kim J, Jang TW, Choi CM, Kim MH, Lee SY, Park CK, Chang YS, et al. Real-world analysis of first-line afatinib in patients with EGFR-mutant non-small cell lung cancer and brain metastasis: survival and prognostic factors. Transl Lung Cancer Res 2023; 12: 1197-209. (Among 703 Korean patients with EGFR mutant NSCLC and brain metastases treated with afatinib the median overall survival was 53 months; no mention of ALT elevations or hepatotoxicity). 37425421
Wang Z, Meng J, Liu G, Wang Y, Li Y, Zhang C, Liu Y, Sun G. Hepatotoxicity and efficacy associated with first- and new-generation EGFR-TKIs in patients with NSCLC: a systematic review and meta-analysis. BMC Cancer 2025; 25: 1909. (Systematic review of 6 randomized placebo controlled trials involving 2,528 patients with NSCLC receiving tyrosine kinase inhibitors of EGFR, found higher overall objective response rates with the newly or yet to be approved agents [afatinib, osimertinib, dacomitinib] vs the initially approved agents, and the newer agents had lower risks of ALT elevations [averaging 8% vs 21%]). 41462168

## OTHER REFERENCE LINKS

1. Recent References on Afatinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Afatinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Afatinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Afatinib)